# Blinatumomab

## OVERVIEW

### Introduction

Blinatumomab is a recombinant mouse derived bispecific monoclonal antibody to the CD3 cell surface antigen found on T lymphocytes and the CD19 site for the targeted (malignant) B lymphocytes. Blinatumomab is approved for use as a second line treatment of relapsed or refractory B cell precursor related acute lymphoblastic leukemia (ALL). Blinatumomabis commonly associated with mild-to-moderate serum enzyme and bilirubin elevations during the first cycle of therapy, but it has not been linked to cases of clinically apparent liver injury.

### Background

Blinatumomab (blin" a toom' oh mab) is a mouse monoclonal IgG1 antibody that has bispecific reactivity to both the CD3 cell surface antigen that is found on normal T cells and the CD19 antigen that is overexpressed on B cell malignancies. The monoclonal antibody binds to T cells and brings them into contact with malignant B cells, allowing them to recognize and eliminate ALL blasts. Blinatumomab has been evaluated in children and adults with relapsed or refractory acute lymphoblastic leukemia (ALL) and shown to induce a high rate of clinical response and to prolong overall survival in comparison to conventional chemotherapy. Blinatumomab was approved for use in patients with Philadelphia chromosome-negative, relapsed or refractory, B cell precursor-related ALL in 2014. Blinatumomab is available as a powder for reconstitution in single use vials of 35 µg under the brand name Blincyto. Blinatumomab is given by constant intravenous infusion in variable daily doses [9 or 28 µg in persons 45 kg or greater] for 28 days per cycle. Side effects are common and can be severe, including infusion reactions, chills, fever, nausea, diarrhea, fatigue, dyspnea, cough, bronchitis, pneumonia, skin rash, neutropenia and infections. Less common, but potentially severe side effects include cutaneous reactions (Stevens Johnson syndrome), tumor lysis syndrome, pancreatitis, neurological toxicities, prolonged neutropenia, thrombocytopenia and anemia. Because of the potential severity of infusion reactions, premedication with dexamethasone with the initial dose or with dose escalations or reinitiation of therapy is necessary. Blinatumomab should be administered under close medical observation and hospitalization for the first 9 days of therapy and for 2 days with subsequent cycles is recommended.

### Hepatotoxicity

Serum aminotransferase elevations are common during blinatumomab therapy, yet are rarely discussed or mentioned in publications on its use in acute leukemia. In summary analyses of laboratory test abnormalities during blinatumomab therapy, ALT elevations were reported to occur in 93% of adult subjects and were above 5 times the upper limit of normal (ULN) in 36%. The elevations arose within the first few days of treatment during the first cycle and elevations were less common and lower with subsequent cycles. Rates of hyperbilirubinemia were also high but all changes were reversible and there were no instances of clinically apparent liver injury attributable to the monoclonal therapy. Subsequent to its approval and more wide scale use, there have been no published instances of clinically apparent liver injury with jaundice attributable to blinatumomab therapy.

Likelihood score: E* (unproven but suspected cause of acute liver injury).

### Mechanism of Injury

The mechanism by which blinatumomab causes liver injury is not known. It is a recombinant protein and unlikely to be inherently hepatoxic, being metabolized to small polypeptides or amino acids by many cells and having no effect on activity of drug metabolizing enzymes or hepatic transporter molecules. The serum enzyme abnormalities that are frequent during therapy may reflect a direct effect of the bispecific monoclonal antibody on hepatocytes or a secondary effect mediated by cytokine release from its action on malignant B cells. Because blinatumomab has effects on immune function and normal B cells, it may also be capable of causing reactivation of hepatitis B in susceptible patients, but instances of this adverse event have not been published.

### Outcome and Management

Guidelines for management of patients who are to receive blinatumomab recommend routine monitoring of liver tests before and during blinatumomab therapy and interrupting treatment if serum aminotransferase levels rise above 5 times ULN or bilirubin above 3 times ULN. Mild-to-moderate elevations in serum aminotransferase levels are common during blinatumomab therapy, particularly in patients who develop cytokine release syndrome.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Blinatumomab – Blincyto®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Blinatumomab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Blinatumomab | 853426-35-4 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 30 September 2017

Abbreviations used: ALL, acute lymphoblastic leukemia; HCT, hematopoietic cell transplantation.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; no specific discussion of blinatumomab).
Chabner BA, Barnes J, Neal J, Olson E, Mujagiv H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-53. (Textbook of pharmacology and therapeutics).
Handgretinger R, Zugmaier G, Henze G, Kreyenberg H, Lang P, von Stackelberg A. Complete remission after blinatumomab-induced donor T-cell activation in three pediatric patients with post-transplant relapsed acute lymphoblastic leukemia. Leukemia 2011; 25: 181-4. (3 children with refractory and relapsed B precursor ALL after HCT responded with complete remission after 4-6 weeks of infusions with blinatumomab with minimal adverse side effects). 20944674
Topp MS, Kufer P, Gökbuget N, Goebeler M, Klinger M, Neumann S, Horst HA, et al. Targeted therapy with the T-cell-engaging antibody blinatumomab of chemotherapy-refractory minimal residual disease in B-lineage acute lymphoblastic leukemia patients results in high response rate and prolonged leukemia-free survival. J Clin Oncol 2011; 29: 2493-8. (Among 20 patients with relapsed ALL or with “minimal residual disease” who were treated with 59 cycles of blinatumomab, 16 had a molecular response but adverse events were frequent including lymphopenia, fever and hypokalemia, and one patient with transient ALT elevations above 5 times ULN). 21576633
Topp MS, Gökbuget N, Zugmaier G, Degenhard E, Goebeler ME, Klinger M, Neumann SA, et al. Long-term follow-up of hematologic relapse-free survival in a phase 2 study of blinatumomab in patients with MRD in B-lineage ALL. Blood 2012; 120: 5185-7. (After a median follow up of 33 months, 61% of the 20 patients with ALL treated with blinatumomab [Topp 2011], were still relapse-free and no further adverse events were reported). 23024237
Teachey DT, Rheingold SR, Maude SL, Zugmaier G, Barrett DM, Seif AE, Nichols KE, et al. Cytokine release syndrome after blinatumomab treatment related to abnormal macrophage activation and ameliorated with cytokine-directed therapy. Blood 2013; 121: 5154-7. (Analysis of clinical features and cytokine levels in a patient with ALL treated with blinatumomab thought to be cytokine release syndrome was considered to be macrophage activation syndrome [MAS] and rapidly responded to toclizumab [anti-IL6] therapy). 23678006
Topp MS, Gökbuget N, Zugmaier G, Klappers P, Stelljes M, Neumann S, Viardot A, et al. Phase II trial of the anti-CD19 bispecific T cell-engager blinatumomab shows hematologic and molecular remissions in patients with relapsed or refractory B-precursor acute lymphoblastic leukemia. J Clin Oncol 2014; 32: 4134-40. (Among 36 patients with relapsed or refractory B-precursor ALL who were treated with blinatumomab, 69% achieved a complete response, and adverse events were common including fever [81%], fatigue [50%], headache [47%], tremor [36%] and leukopenia [19%]; no mention of ALT elevations or hepatotoxicity). 25385737
Di Bisceglie AM, Lok AS, Martin P, Terrault N, Perrillo RP, Hoofnagle JH. Recent US Food and Drug Administration warnings on hepatitis B reactivation with immune-suppressing and anticancer drugs: just the tip of the iceberg? Hepatology 2015; 61: 703-11. (Review of the pathogenesis, clinical course, treatment and prevention of HBV reactivation in patients receiving immunosuppressive or anticancer therapies, with particular focus on rituximab and ofatumumab; no mention of blinatumomab). 25412906
Topp MS, Gökbuget N, Stein AS, Zugmaier G, O'Brien S, Bargou RC, Dombret H, et al. Safety and activity of blinatumomab for adult patients with relapsed or refractory B-precursor acute lymphoblastic leukaemia: a multicentre, single-arm, phase 2 study. Lancet Oncol 2015; 16: 57-66. (Among 189 patients with refractory or relapsed B-precursor ALL treated with blinatumomab, 33% had a complete response, 2% had cytokine release syndrome, 11% neurological complications, and 13% had ALT elevations which were above 5 times ULN in 6%; no mention of clinically apparent hepatotoxicity). 25524800
Zugmaier G, Gökbuget N, Klinger M, Viardot A, Stelljes M, Neumann S, Horst HA, et al. Long-term survival and T-cell kinetics in relapsed/refractory ALL patients who achieved MRD response after blinatumomab treatment. Blood 2015; 126: 2578-84. (Among 36 adults with relapsed or refractor B-precursor ALL treated with blinatumomab, 10 [28%] were long term survivors and serious adverse events included convulsions, encephalopathy and cytokine release syndrome; no mention of ALT elevations or hepatotoxicity). 26480933
Viardot A, Goebeler ME, Hess G, Neumann S, Pfreundschuh M, Adrian N, Zettl F, et al. Phase 2 study of the bispecific T-cell engager (BiTE) antibody blinatumomab in relapsed/refractory diffuse large B-cell lymphoma. Blood 2016; 127: 1410-6. (Among 21 patients with relapsed or refractory B-precursor ALL treated with blinatumomab, there were no liver related serious adverse events or deaths; ALT elevations were not reported). 26755709
Goebeler ME, Knop S, Viardot A, Kufer P, Topp MS, Einsele H, Noppeney R, et al. Bispecific T-Cell engager (BiTE) antibody construct blinatumomab for the treatment of patients with relapsed/refractory non-Hodgkin lymphoma: final results from a phase I study. J Clin Oncol 2016; 34: 1104-11. (Among 76 patients with relapsed or refractory non-Hodgkin lymphoma treated with blinatumomab, neurologic events were dose limiting and at 60 µg/m2 per day, the overall response rate was 69%, neurologic adverse events occurred in 22% and ALT elevations in 33%, but none were above 5 times ULN). 26884582
Przepiorka D, Ko CW, Deisseroth A, Yancey CL, Candau-Chacon R, Chiu HJ, Gehrke BJ, Gomez-Broughton C, et al. FDA approval: blinatumomab. Clin Cancer Res 2015; 21: 4035-9. (Summary of the clinical studies that supported the FDA approval of blinatumomab for treatment of relapsed or refractory precursor B cell ALL; summary safety results from 212 treated adults mentions ALT elevations occurring in more than 10% of patients, but that “elevated transaminases generally occurred in the setting of cytokine release syndrome”). 26374073
Blinatumomab (Blincyto) for acute lymphoblastic leukemia. Med Lett Drugs Ther 2015; 57 (1468): e74-5. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of blinatumomab shortly after its approval in the US; no mention of ALT elevations or hepatotoxicity). 25941958
von Stackelberg A, Locatelli F, Zugmaier G, Handgretinger R, Trippett TM, Rizzari C, Bader P, et al. Phase I/phase II study of blinatumomab in pediatric patients with relapsed/refractory acute lymphoblastic leukemia. J Clin Oncol 2016; 34: 4381-9. (Among 93 pediatric patients with relapsed or refractory ALL treated with varying doses of blinatumomab, 39% had a complete response to the optimal dose and the most frequent serious adverse events were anemia, thrombocytopenia and hypokalemia, while 4 patients had cytokine release syndrome and 2 seizures; ALT elevations above 5 times ULN occurred in 16%). 27998223
Kantarjian H, Stein A, Gökbuget N, Fielding AK, Schuh AC, Ribera JM, Wei A, et al. Blinatumomab versus chemotherapy for advanced acute lymphoblastic leukemia. N Engl J Med 2017; 376: 836-47. (Among 405 patients with relapsed or refractory ALL treated with blinatumomab or standard chemotherapy, overall median survival was greater with blinatumomab [7.7 vs 4.0 months] and adverse events rates were similar [98.5% vs 99.1%]; although serious adverse events were higher with blinatumomab [62% vs 45%] but liver enzyme elevations were not [12.7% vs 14.7%]). 28249141
Burki TK. Blinatumomab significantly improves overall survival. Lancet Oncol 2017; 18: e203. (News report summarizing the controlled trial of blinatumomab that showed an improvement in overall survival in relapsed and refractory ALL [Kantarjian 2017]). 28285842
Nägele V, Kratzer A, Zugmaier G, Holland C, Hijazi Y, Topp MS, Gökbuget N, et al. Changes in clinical laboratory parameters and pharmacodynamic markers in response to blinatumomab treatment of patients with relapsed/refractory ALL. Exp Hematol Oncol 2017; 6: 14. (Among 36 adults with relapsed or refractory ALL treated with blinatumomab, ALT, AST and bilirubin levels rose within 24 hours of starting infusions and declined to baseline by the end of the cycle, but rose minimally with subsequent cycles, elevations being mild-to-moderate in degree and fully reversible, corresponding to the timing of cytokine release). 28533941

## OTHER REFERENCE LINKS

1. Recent References on Blinatumomab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Blinatumomab/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Blinatumomab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Blinatumomab)